# Nux Vomica

## OVERVIEW

### Introduction

Nux vomica is an extract of the seeds of the Strychos nux-vomica or strychnine tree used in traditional and homeopathic medicine with purported benefits for a wide range of conditions including heart disease and cancer. Nux vomica contains strychnine and brucine, two toxic alkaloids banned or severely restricted in most countries. The toxicity of Nux vomica is manifested by neuromuscular hyperexcitability with agitation and muscular spasms followed by convulsions, rhabdomyolysis, metabolic acidosis and respiratory and cardiac arrest. Ingestion of Nux vomica has not been shown to cause serum aminotransferase elevations or liver injury.

### Background

Nux vomica is prepared from the seeds of the Strynos nux-vomica tree, which is native to India and Southeast Asia. The dried, processed seeds have been used in Ayurvedic and traditional Asian medicine for a wide variety of conditions including gastritis, constipation, influenza, arthritis, musculoskeletal disorders, heart disease and cancer. However, the Nux vomica seeds also contain appreciable concentrations of the alkaloid poisons strychnine and brucine. Strychnine is a well known toxin which is associated with both intentional and accidental poisoning for which reason it is banned or restricted in most countries of the world, being used only in baits to kill feral animals such as rats and moles. While strychnine and brucine have antineoplastic, antiinflammatory and antioxidant activity in cell culture, the therapeutic window of their effects is narrow, and they have not been shown to have beneficial medicinal effects in prospective studies in humans. Nevertheless, Nux vomica products can been purchased on the internet and in nutrition stores and are generally recommended for indigestion, nausea, vomiting and as a hangover cure. The Nux vomica seeds are typically dried and processed resulting in a decrease in the concentration of the toxic alkaloids. Indeed, testing currently available commercial products by sensitive analytic methods often fails to detect either strychnine or brucine. The toxicity of strychnine is due to its inhibition of postsynaptic, neuroinhibitory glycine receptors found in the spinal cord and central nervous system. Toxicity arises within a few hours of ingestion of Nux vomica seeds with anxiety, agitation, heightened sensation, twitching, and muscular spasms, which can progress to convulsions while conscious, chest and back pain, hyperthermia, rhabdomyolysis, renal dysfunction, and respiratory or cardiac failure. In severe cases death occurs within 24 hours of the ingestion. Mild cases may have transient agitation and muscle spasms lasting only a few hours.

### Hepatotoxicity

Small prospective studies of extracts of Nux vomica do not mention serum aminotransferase elevations or acute liver injury, but also did not generally include monitoring of liver tests. There have been no reports of acute liver injury attributed to use of Nux vomica products. Descriptions of the toxicity of strychnine and Nux vomica have not mentioned acute liver injury and in several case reports serum enzyme levels have been reported to be normal at the time of initial presentation. Some fatal cases have been attributed to multiorgan failure, probably the result of shock and hyperthermia.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism of toxicity of Nux vomica appears to be due to the toxic alkaloids, strychnine and brucine, which act by blocking neuroinhibitory, postsynaptic glycine receptors which results in muscle hyperexcitability, spasms, tonic-clonic muscular activity, and with higher doses, paralysis of pulmonary musculature and respiratory failure.

### Outcome and Management

Hepatotoxicity from extracts of Nux vomica has not been reported.

Drug Class: Herbal and Dietary Supplements

Other names: Strychnine, Poison Fruit, Slang Nuts.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Nux vomica – Generic

DRUG CLASS

Herbal and Dietary Supplements

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Brucine | 357-57-3 | C23-H26-N2-O4
Strychnine | 57-24-9 | C21-H22-N2-O2

## ANNOTATED BIBLIOGRAPHY

References updated: 03 March 2023

Abbreviations: HDS, herbal and dietary supplements.

Zimmerman HJ. Unconventional drugs. Miscellaneous drugs and diagnostic chemicals. In, Zimmerman, HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999: pp. 731-4. (Expert review of hepatotoxicity published in 1999; several herbal medications are discussed, but not Nux vomica).
Liu LU, Schiano TD. Hepatotoxicity of herbal medicines, vitamins and natural hepatotoxins. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 2nd ed. New York: Informa Healthcare USA, 2007, pp. 733-54. (Review of hepatotoxicity of herbal and dietary supplements [HDS] published in 2007; no mention of Nux vomica).
Nux vomica. In, PDR for Herbal Medicines. 4th ed. Montvale, New Jersey: Thomson Healthcare Inc. 2007: pp. 607-9. (Compilation of short monographs on herbal medications and dietary supplements).
O'Callaghan WG, Joyce N, Counihan HE, Ward M, Lavelle P, O'Brien E. (1982). Unusual strychnine poisoning and its treatment: report of eight cases. Br Med J (Clin Res Ed). (Eight persons developed acute strychnine poisoning within 30 minutes of inhaling a white powder thought to be cocaine; one patient dying of cardiac arrest, the others with varying degrees of muscle spasms and convulsions all having raised CPK levels; no mention of liver injury or serum aminotransferase levels).
Boyd RE, Brennan PT, Deng JF, Rochester DF, Spyker DA. (1983). Strychnine poisoning. Recovery from profound lactic acidosis, hyperthermia, and rhabdomyolysis. Am J Med. (42 year old man ingested strychnine and developed progressive muscle spasms, respiratory arrest, metabolic acidosis, renal failure, hyperthermia and muscle injury [CPK 8218 U/L] and was treated with paralysis, artificial ventilation, fluid replacement, treatment of acidosis and he eventually recovered; no mention of liver injury or serum aminotransferase levels).
Katz J, Prescott K, Woolf AD. (1996). Strychnine poisoning from a Cambodian traditional remedy. Am J Emerg Med. (58 year old Cambodian woman developed dizziness, abdominal pain, muscle spasms, and “awake” seizures shortly after ingestion of “slang nut” and was admitted with lactic acidosis, recovering with supportive therapy, testing of the product revealed it to be seeds from the Strychnos nux-vomica tree).
Chan TY. (2002). Herbal medicine causing likely strychnine poisoning. Hum Exp Toxicol. (A 42 year old woman treated with “magianzi” prepared from dried and processed Nux Vomica seeds developed tonic contractures of the limb muscles, perioral numbness, chest tightness and difficulty breathing within hours of drinking a second bowl of a herbalist prescribed herbal decoction, ultimately recovering with supportive therapy; liver function tests were said to be normal).
Barquero Romero J, Redondo López JM, Galeano Díaz F, Pérez Miranda M. (2004). Med Clin (Barc). (67 year old man with type 2 diabetes developed severe epigastric pain and nausea 2 weeks after starting a homeopathic medication that included Nux vomica and Rhys Toxicodendron [Atlantic poison oak], evaluation revealed an acute hemorrhagic and ultimately fatal pancreatitis despite absence of history of clinical evidence of alcohol use, gallstones or liver injury [ALT 38 U/L, AST 27 U/L]).
Jacobsson I, Jönsson AK, Gerdén B, Hägg S. (2009). Spontaneously reported adverse reactions in association with complementary and alternative medicine substances in Sweden. Pharmacoepidemiol Drug Saf. (Review of 778 spontaneous reports of adverse reactions to herbals to Swedish Registry found no cases attributed to Nux vomica).
Reuben A, Koch DG, Lee WM, Acute Liver Failure Study Group. (2010). Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 [11%] were attributed to drug induced liver injury of which 12 [9%] were due to herbals, including several herbal mixtures, usnic acid, Ma Huang, black cohosh, and Hydroxycut, but not Nux vomica).
Parker AJ, Lee JB, Redman J, Jolliffe L. (2011). Strychnine poisoning: gone but not forgotten. Emerg Med J. (49 year old woman developed acute agitation followed by muscle spasms within hours of suicidal ingestion of strychnine with progressive respiratory failure, lactic acidosis and CK levels rising from normal to 6262 U/L by day 2, but ultimate recover; no mention of liver injury or serum aminotransferase elevations).
Achappa B, Madi D, Babu YP, Mahalingam S. (2012). Rituals can kill – A fatal case of brucine poisoning. Australas Med J. (29 year old man developed intractable and ultimately fatal convulsions within hours of drinking a decoction that he made from the bark of a strychnine tree that he had mistaken for a Alsonia scholar tree, which had been used by his family in a yearly celebration; no mention of liver test abnormalities).
Teschke R, Wolff A, Frenzel C, Schulze J, Eickhoff A. (2012). Herbal hepatotoxicity: a tabular compilation of reported cases. Liver Int. (A systematic compilation of all publications on the hepatotoxicity of specific herbals identified 185 publications on 60 different herbs, herbal drugs and supplements but does not list or mention Nux vomica).
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. (2013). Incidence, presentation and outcomes in patients with drug-induced liver injury in the General population of Iceland. Gastroenterology. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, 15 of which [16%] were attributed to HDS products, but none were listed as containing Nux vomica).
Bunchorntavakul C, Reddy KR. (2013). Review article: herbal and dietary supplement hepatotoxicity. Aliment Pharmacol Ther. (Systematic review of literature on HDS associated liver injury does not mention Arnica montana).
Navarro VJ, Seeff LB. (2013). Liver injury induced by herbal complementary and alternative medicine. Clin Liver Dis. (Review of the epidemiology, regulatory status, diagnosis, pathogenesis and causes of liver injury from herbal products with specific discussion of conjugated linoleic acid, ephedra, germander, green tea, usnic acid, flavocoxid, aloe vera, chaparral, greater celandine, black cohosh, comfrey, kava, skullcap, valerian, noni juice, pennyroyal and traditional herbal remedies).
Navarro VJ, Barnhart H, Bonkovsky HL, Davern T, Fontana RJ, Grant L, Reddy KR, et al. (2014). Liver injury from herbals and dietary supplements in the U.S. Drug-Induced Liver Injury Network. Hepatology. (Among 839 cases of liver injury from drugs collected in the US between 2004 and 2013, 130 were due to HDS products, including 45 from body building agents [probably anabolic steroids] and 85 from diverse HDS products but no case was attributed specifically to Nux vomica).
Prat S, Hoizey G, Lefrancq T, Saint-Martin P. (2015). An unusual case of strychnine poisoning. J Forensic Sci. (A 69 year old Canadian man was found dead at home, apparently after suicidal ingestion of rat poison with high levels of strychnine).
Ponraj L, Mishra AK, Koshy M, Carey RAB. (2017). A rare case report of Strychnos nux-vomica poisoning with bradycardia. J Family Med Prim Care. (39 year old Indian man made a concoction with 6 leaves of the Strychnos nux-vomica tree, and rapidly developed vomiting, agitation, muscle twitches and muscle tenderness followed by bradycardia and electrocardiographic changes, but with normal blood tests and full recovery within a few days).
Singhapricha T, Pomerleau AC. (2017). A case of strychnine poisoning from a Southeast Asian herbal remedy. J Emerg Med. (40 year old Cambodian woman presented with jaw pain and muscle spasms and strychnine detected in plasma and urine a few hours after drinking from a bottle that she thought was vodka but was actually “slang nuts”, a local preparation of Nux vomica seeds; recovering with supportive care; no mention of hepatic injury).
Brown AC. (2017). Liver toxicity related to herbs and dietary supplements: Online table of case reports. Part 2 of 5 series. Food Chem Toxicol. (Description of an online compendium of cases of liver toxicity attributed to HDS products, does not list or discuss Nux vomica).
Medina-Caliz I, Garcia-Cortes M, Gonzalez-Jimenez A, Cabello MR, Robles-Diaz M, Sanabria-Cabrera J, Sanjuan-Jimenez R, et al., Spanish DILI Registry. (2018). Herbal and dietary supplement-induced liver injuries in the Spanish DILI Registry. Clin Gastroenterol Hepatol. (Among 856 cases of hepatotoxicity enrolled in the Spanish DILI Registry between 1994 and 2016, 32 were attributed to herbal products, the most frequent cause being green tea [n=8] and Herbalife products [n=6], no mention of Nux vomica).
Lu L, Huang R, Wu Y, Jin JM, Chen HZ, Zhang LJ, Luan X. (2020). Brucine: A review of phytochemistry, pharmacology, and toxicology. Front Pharmacol. (Review of the chemistry, pharmacology and toxicity of brucine, a major component found in Nux vomica seeds which has antineoplastic and antiinflammatory activities in vitro but a narrow therapeutic window; “although brucine has an impressive preclinical profile in pharmacology research, serious toxicity limits its clinical applications” ).
Downs J, Wolf CE, Williams G, Cumpston KL, Kershner E, Wills BK. (2021). Negligible Nux vomica: homeopathic Nux vomica remedies don't contain strychnine?. Toxicon. (None of a number of Nux vomica products purchased from homeopathic medicine and nutrition stores tested positive for strychnine or brucine using sensitive high-pressure liquid chromatography assays).
Abhilash KP, Murugan S, Rabbi AS, Pradeeptha S, Pradeep R, Gunasekaran K. (2021). Deliberate self-poisoning due to plant toxins: verdant footprints of the past into the present. Indian J Crit Care Med. (Among 150 patients seen over a 2 year period in an emergency room in South India with deliberate self-poisoning with plant products, the mortality rate was 9%, most were due to oleander [59%] or aduvanthalai [31%], but 4 were due to Nux vomica, all of which survived).
Ballotin VR, Bigarella LG, Brandão ABM, Balbinot RA, Balbinot SS, Soldera J. (2021). Herb-induced liver injury: Systematic review and meta-analysis. World J Clin Cases. (Systematic review of the literature on herb induced liver injury identified 446 references describing 936 cases due to 79 different herbal products, the most common being He Shou Wu [91], green tea [90] Herbalife products [64], kava kava [62] and greater celandine [48]; Nux vomica is not discussed).
Bessone F, García-Cortés M, Medina-Caliz I, Hernandez N, Parana R, Mendizabal M, Schinoni MI, et al. (2022). Herbal and dietary supplements-induced liver injury in Latin America: experience from the LATINDILI Network. Clin Gastroenterol Hepatol. (Among 367 cases of hepatotoxicity enrolled in the Latin American DILI Network between 2011 and 2019, 29 [8%] were attributed to herbal products, the most frequent being green tea [n=7], Herbalife products [n=5] and garcinia [n=3], while Nux vomica is not mentioned).

## OTHER REFERENCE LINKS

1 Recent References on Nux vomica: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Nux+vomica+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Nux vomica: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Nux%20vomica)